# Penicillins (2nd Generation)

## OVERVIEW

The penicillinase-resistant penicillins [also referred to as second generation penicillins] are semisynthetic modifications of natural penicillins that are resistant to the bacterial enzyme beta-lactamase, which accounts for typical penicillin resistance. The natural penicillins from which the second generation penicillins are made are bactericidal antibiotics naturally derived from the mold, Penicillium chrysogenum. Their basic structure includes a thiazolidine ring connected to a beta-lactam ring with a variable side chain. As a class, the penicillins bind to bacterial proteins and inhibit synthesis of the bacterial cell wall, causing cell lysis particularly in rapidly growing organisms. Bacterial resistance to penicillin is usually mediated by beta-lactamase, an enzyme which destroys the beta-lactam ring of penicillin, rendering it inactive. The penicillinase-resistant penicillins resist the hydrolysis of the beta-lactam ring by the bacterial enzymes. They are active against most organisms that are susceptible to the natural penicillins (although less active than penicillin G) and have extended coverage against resistant forms.

### Background

Three major penicillinase-resistant penicillins are available in the United States: dicloxacillin (dye klox" a sil' in), oxacillin (ox" a sil' in) and nafcillin (naf sil' in). Dicloxacillin is orally available; oxacillin is available only in parenteral forms, while nafcillin has both oral and parenteral formulations. Parenteral forms are given by either intramuscular or intravenous routes. Other formulations available abroad or in the past include methicillin, cloxacillin, carbenicillin, and flucloxacillin, which have been associated with a higher frequency of side effects including renal and hepatic injury. The major indications for dicloxacillin, oxacillin, and nafcillin are moderate-to-serious infections with susceptible penicillinase-producing staphylococci; these agents are also active against organisms susceptible to natural penicillins, but are less active than the natural penicillins.

### Hepatotoxicity

Three forms of liver injury have been attributed to the penicillinase-resistant and other penicillins. The first is a transient and usually asymptomatic elevation in serum aminotransferase levels that occurs with high dose intravenous therapy with oxacillin (Case 1, Oxacillin) and rarely with standard penicillins (Case 1, Penicillin G). This reaction has not been described with nafcillin or dicloxacillin and patients can be safety switched to these or other forms of penicillin in the face of oxacillin injury. This form of penicillin-induced liver injury occurs only with high dose therapy that is likely due to direct hepatotoxicity. The injury is usually asymptomatic and benign, resolving rapidly once therapy is stopped.

The second form of hepatotoxicity occurs in patients with hypersensitivity reactions to the penicillin (Case 2, Penicillin G). Generally, the liver injury is mild and is overshadowed by the allergic phenomena (rash, fever, facial edema, anaphylaxis). Mild elevations of serum aminotransferase or alkaline phosphatase without jaundice are not uncommon in patients with severe penicillin reactions, and the abnormalities generally resolve rapidly with improvement in the allergic features.

The third form of hepatotoxicity is an idiosyncratic, usually self-limited cholestatic hepatitis that occurs within 1 to 6 weeks of initiation of therapy and is quite rare, described only in single case reports with oxacillin, nafcillin and dicloxacillin (Case 1, nafcillin and Case 1, dicloxacillin). This injury probably represents a class effect and patients who develop idiosyncratic liver injury due to one of the penicillinase-resistant penicillins should avoid other agents in this class. This type of reaction is much more common with flucloxacillin, an agent that is available in Australia and some countries in Europe, but not in the United States. In addition, rare cases of flucloxacillin associated liver injury have resulted in vanishing bile duct syndrome has well as instances of acute liver failure leading to liver transplantation or death. These more serious complications of drug induced liver injury have been less frequent with use of the other penicillinase-resistant penicillins.

The idiosyncratic hepatic injury caused by the second generation penicillins is probably due to hypersensitivity. The role of immunologic pathways in liver injury has been best shown with flucloxacillin, which is strongly associated with the presence of the HLA-B*57:01 allele (which also predicts abacavir hypersensitivity). Immunologic studies have begun to elucidate the reasons for the HLA association and hypersensitivity to abacavir and flucloxacillin, and a similar mechanism possibly underlies the idiosyncratic, typically cholestatic jaundice caused by dicloxacillin and other second generation penicillins. However, the incidence of liver injury due to flucloxacillin and dicloxacillin is rare and is uncommon even among persons with HLA-B*57:01, so that screening for this allele is unlikely to be practicable in preparation of using these antibiotics.

Drug Class: Antiinfective Agents

Dicloxacillin, nafcillin, and oxacillin are discussed separately with individual clinical cases, histology and specific references. General references to the hepatotoxicity of the 2^nd^ generation penicillins and to cloxacillin, methicillin, and flucloxacillin are given below.

The following are links to each drug record:

• Dicloxacillin

• Nafcillin

• Oxacillin

• Cloxacillin

• Flucloxacillin

• Methicillin

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Cloxacillin | 61-72-3 | C19-H18-Cl-N3-O5-S | SID: 134971202
Dicloxacillin | 3116-76-5 | C19-H17-Cl2-N3-O5-S | SID: 134981835
Flucloxacillin Floxacillin [USAN] | 5250-39-5 | C19-H17-Cl-F-N3-O5-S | SID: 134984533
Methicillin | 61-32-5 | C17-H20-N2-O6-S | SID: 134970879
Nafcillin | 147-52-4 | C21-H22-N2-O5-S | SID: 134975099
Oxacillin | 66-79-5 | C19-H19-N3-O5-S | SID: 134972946

## ANNOTATED BIBLIOGRAPHY

References updated: 9 August 2026

Zimmerman HJ. Synthetic penicillins. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 596-8. (Expert review of penicillins and liver injury published in 1999).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics mentions that liver injury from the penicillins is very rare, and is usually cholestatic for the oxypenicillins such as dicloxacillin and cloxacillin).
MacDougall C. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1023-38. (Textbook of pharmacology and therapeutics).
Freedman MA. Oxacillin—apparent hematologic and hepatic toxicity. Rocky Mt Med J 1965; 62: 34-6. (33 year old woman developed AST elevations to ~220 U/L, atypical lymphocytosis and eosinophilia after 2.5 months of high dose oral oxacillin, complicated by bone marrow suppression and breakthrough in chronic osteomyelitis).
Pas AT, Quinn EL. Cholestatic hepatitis following the administration of sodium oxacillin. JAMA 1965; 191: 674-5. (65 year old woman developed itching and jaundice the week after stopping a 4 week course of oral oxacillin [bilirubin 2.2 mg/dL, Alk P ~twice elevated, AST 76 U/L], resolving within 8 weeks). 14242432
Dismukes WE. Oxacillin-induced hepatic dysfunction. JAMA 1973; 226: 861-3. (3 cases of ALT elevations, fever and nausea arising 11-24 days after starting high dose intravenous oxacillin therapy, with rapid reversal on stopping). 4800332
Olans RN, Weiner LB. Reversible oxacillin hepatotoxicity. J Pediatr 1976; 89: 835-8. (8 instances of ALT elevations [peak values 31-1359 U/L] without jaundice [2 had eosinophilia] after 8-25 days of intravenous oxacillin in children or young adults, with rapid resolution; no recurrence when switched to nafcillin). 978335
Bruckstein AH, Attia AA. Oxacillin hepatitis. Two patients with liver biopsy, and review of the literature. Am J Med 1978; 64: 519-22. (Two injection drug users treated with high dose oxacillin [12-16 g/day] for endocarditis developed increased AST levels [10-40 times ULN], with mild symptoms but no change in Alk P or bilirubin and nonspecific biopsy findings, arising after 2-3 weeks and resolving rapidly with stopping). 637061
Goldstein LI, Granoff M, Waisman J. Hepatic injury due to oxacillin administration. Am J Gastroenterol 1978; 70: 171-4. (21 year old male injection drug used developed aminotransferase elevations [ALT 806 U/L, AST 388 U/L, 15% eosinophils] 20 days after starting intravenous oxacillin [12 g/day], with biopsy showing hepatitis, rapid recovery). 717369
Onorato IM, Axelrod JL. Hepatitis from intravenous high-dose oxacillin therapy: findings in an adult inpatient population. Ann Intern Med 1978; 89: 497-500. (Review of experience with high dose oxacillin revealed 8 cases of liver injury, rising 3-19 days after start of therapy with fever and mild GI symptoms, ALT 2 to 15 times ULN, Alk P minimally increased, and no jaundice; resolving in 1 week; compared to control group, a history of penicillin allergy was given in 3 cases, but not controls). 697229
D'Angelo LJ. Oxacillin and hepatotoxicity. Ann Intern Med 1979; 90: 442. (Letter commenting on article by Onorato & Axelrod, without new data).
Taylor C, Corrigan K, Steen S, Craig C. Oxacillin and hepatitis. Ann Intern Med 1979; 90: 857-8. (Letter in response to Onorato & Axelrod describing 24 year old man who developed ALT elevations [226 U/], with rash and eosinophilia after 27 days of intravenous oxacillin therapy [8 g/day], rapidly resolving upon switching to nafcillin). 434706
Pollock AA, Berger SA, Simberkoff MS, Rahal JJ Jr. Hepatitis associated with high-dose oxacillin therapy. Arch Intern Med 1978; 138: 915-7. (Prospective study of liver tests in 41 patients during intravenous oxacillin therapy; 15 had ALT elevations, but only 5 were attributed to oxacillin, 12-23 g/day arising 5-24 days after starting, peak ALT values 5-20 times ULN, mild Alk P elevation in 4, but normal bilirubin in all, and resolution in 4-16 days of stopping; no eosinophilia, fever or symptoms). 646563
Halloran TJ, Clague MD. Hepatitis associated with high-dose oxacillin therapy. Arch Intern Med 1979; 139: 376-7. (Letter in response to Pollock [1978] describing 16 year old girl with no history of injection drug use who developed AST elevations [peak 140 U/L], starting after 9 days of intravenous oxacillin, rapid resolution upon stopping).
Enat R, Pollack S, Ben-Arieh Y, Livni E, Barzilai D. Cholestatic jaundice caused by cloxacillin: macrophage inhibition factor test in preventing rechallenge with hepatotoxic drugs. Br Med J 1980; 280: 982-3. (69 year old woman developed jaundice 2 weeks after a course of ampicillin and cloxacillin [bilirubin 14.9 mg/dL, AST normal, Alk P ~5 times ULN], with recurrence within 4 days of rechallenge [bilirubin 9.3 mg/dL, ALT normal, Alk P twice ULN], positive macrophage inhibition factor test). 7417768
Williams CN, Malatjalian DA. Severe penicillin-induced cholestasis in a 91-year-old woman. Dig Dis Sci 1981; 26: 470-3. (91 year old woman was given both penicillin G and cloxacillin for 11 days when cholestatic hepatitis arose, bilirubin rising to 24 mg/dL, but recovery in 2 months, most likely due to cloxacillin). 7249889
Lobatto S, Dijkmans BA, Mattie H, Van Hooff JP. Flucloxacillin-associated liver damage. Neth J Med. 1982; 25: 47-8. (63 year old woman on renal dialysis had mild ALT elevation [twice ULN] after a few days of intravenous floxacillin and cloxacillin, with positive rechallenge to oral flucloxacillin [ALT rose from 14 to 74 U/L within 1 day]). 7070561
Nahata MC, DeBolt SL, Powell DA. Adverse effects of methicillin, nafcillin and oxacillin in pediatric patients. Dev Pharmacol Ther 1982; 4: 117-23. (Prospective study of children treated with intravenous methicillin [28], nafcillin [32] or oxacillin [8]; minimal ALT elevations occurred in 1 on nafcillin and 1 on oxacillin; no jaundice). 7172968
Miller WI, Souney PF, Chang JT. Hepatic dysfunction following nafcillin and cephalothin therapy in a patient with a history of oxacillin hepatitis. Clin Pharm 1983; 2: 465-8. (Mild ALT elevations after 13 days of high dose oxacillin [18 g/day], similar increase after nafcillin and again with cephalosporin in a male injection drug user with probable chronic hepatitis C, which might have accounted for ALT fluctuations). 6627877
Bengtsson F, Florén CH, Hägerstrand I, Söderström C, Aberg T. Flucloxacillin-induced cholestatic liver damage. Scand J Infect Dis 1985; 17: 125-8. (2 cases of cholestatic hepatitis of moderate severity arising 4-5 weeks after starting oral cloxacillin, resolution in 6-8 weeks). 3992199
Tauris P, Jørgensen NF, Petersen CM, Albertsen K. Prolonged severe cholestasis induced by oxacillin derivatives. A report on two cases. Acta Med Scand 1985; 217: 567-9. (2 case reports: 65 year old man with osteomyelitis developed jaundice and pruritus 6 weeks after starting flucloxacillin [bilirubin ~10 mg/dL, AST 1.5 times ULN, Alk P 3 times ULN], biopsy showing cholestasis, resolving within 8 weeks of stopping; 21 year old man with osteomyelitis developed jaundice 9 weeks after starting dicloxacillin [bilirubin ~4 mg/dL, AST 119 U/L, Alk P 814 U/L], resolving within 6 weeks of stopping). 4025011
Aderka D, Livni E, Salamon F, Weinberger A, Pinkhas J. Use of macrophage inhibition factor and mast-cell degranulation tests for diagnosis of cloxacillin-induced cholestasis. Am J Gastroenterol 1986; 81: 1084-6. (58 year old man took 10 days of cloxacillin and developed jaundice 3 days later [peak bilirubin 18.7 mg/dL, ALT 450 U/L, Alk P 436 IU, no eosinophilia]; had positive macrophage inhibition factor and mast cell degranulation tests in response to cloxacillin). 3776960
Kleinman MS, Presberg JE. Cholestatic hepatitis after dicloxacillin-sodium therapy. J Clin Gastroenterol 1986; 8: 77-8. (56 year old man developed jaundice and pruritus 2-3 weeks after a 5 day course of dicloxacillin [bilirubin rising to 13 mg/dL, AST 225 U/L, Alk P 318 U/L], without rash, eosinophilia or fever, requiring 10 weeks to resolve). 3701014
Konikoff F, Alcalay J, Halevy J. Cloxacillin-induced cholestatic jaundice. Am J Gastroenterol 1986; 81: 1082-3. (77 year old woman developed fever and pruritus 5 days after starting oral cloxacillin [bilirubin 3.6 mg/dL, AST 97 U/L, Alk P 497 U/L], resolving within 5 weeks; history revealed a similar response to a previous course of oral cloxacillin, thus explaining the short latency period). 3776959
Deboever G. Cholestatic jaundice due to derivatives of oxacillin. Am J Gastroenterol 1987; 82: 483. (Letter in response to Konikoff [1986] describing 75 year old woman with cholestatic hepatitis [bilirubin 12.8 mg/dL, ALT 57 U/L, Alk P 868 U/L] arising 3 days after starting flucloxacillin, resolving in 2 months). 3578231
Victorino RM, Maria VA, Correia AP, de Moura C. Floxacillin-induced cholestatic hepatitis with evidence of lymphocyte sensitization. Arch Intern Med 1987; 147: 987-9. (45 year old man developed prolonged cholestatic hepatitis arising 15 days after starting oral floxacillin [bilirubin rising from 11 to 40.6 mg/dL, ALT 490 U/L, Alk P 171 U/L], ultimately responding to prednisone therapy). 3579450
[Risk of liver reactions after treatment with flucloxacillin] Lakartidningen 1989; 86: 977-8. Swedish.
Turner IB, Eckstein RP, Riley JW, Lunzer MR. Prolonged hepatic cholestasis after flucloxacillin therapy. Med J Aust 1989; 151: 701-5. (5 cases of cholestatic hepatitis arising after stopping flucloxacillin, latency 13-35 days [bilirubin 13.3-38.2 mg/dL, ALT 85-525 U/L, Alk P 263-1580 U/L], with prolonged jaundice and abnormal liver tests still present 4-9 months later). 2593915
Miros M, Kerlin P, Walker N, Harris O. Flucloxacillin induced delayed cholestatic hepatitis. Aust N Z J Med 1990; 20: 251-3. (6 cases of cholestatic hepatitis 17-28 days after starting flucloxacillin, with prolonged course and 3 who still had marked Alk P elevations 6 months later). 2372276
Pascual J, Orofino L, Marcén R, Quereda C, Ortuño J. Cloxacillin-induced cholestasis in a renal allograft patient with chronic hepatitis. Am J Gastroenterol 1990; 85: 335-6. (Man with renal transplant and advanced chronic hepatitis C developed sudden onset of itching and worsening of jaundice [bilirubin rising from 4.1 to 22 mg/dL] 3 days after starting intravenous cloxacillin [8 grams/day], with rapid reversal on stopping). 2106780
Fairley CK, Boyd I, Purcell P, McNeil J. Flucloxacillin jaundice. Lancet 1992; 339: 679. (Letter describing increase use of flucloxacillin in Australia [from 12,136 in 1986 to 1,000,000 prescriptions yearly in 1990] and increasing adverse events reported [from 4 in 1987 to 64 in 1990]; worldwide, 255 hepatic adverse events reported).
Lestico MR, Vick KE, Hetsko CM. Hepatic and renal dysfunction following nafcillin administration. Ann Pharmacother 1992; 26: 985-90. (Four cases of elevations in creatinine, BUN and bilirubin within 4 days of starting iv nafcillin, but most patients had abnormal liver tests before therapy; minimal change in AST and Alk P and all patients were septic and also received rifampin and/or gentamicin). 1504413
Olsson R, Wiholm BE, Sand C, Zettergren L, Hultcrantz R, Myrhed M. Liver damage from flucloxacillin, cloxacillin and dicloxacillin. J Hepatol 1992; 15: 154-61. (54 year old woman developed prolonged cholestasis [peak bilirubin 24 mg/dL] after an 18 day course of flucloxacillin leading to cirrhosis and liver transplantation 7 years later; possibly vanishing bile duct syndrome. In a review of Swedish adverse drug reaction reports, 77 flucloxacillin cases were found between 1981-90 compared to only 16 for dicloxacillin and 9 for cloxacillin, fever and eosinophilia in half, mostly cholestatic and mixed enzymes, occasional hepatocellular, older age was a risk factor). 1506634
Derby LE, Jick H, Henry DA, Dean AD. Cholestatic hepatitis associated with flucloxacillin. Med J Aust 1993; 158: 596-600. (Survey of 600 general practices in the UK with 132,087 patients who received flucloxacillin, 10 cases of unexplained cholestatic liver injury <45 days [mean~4 weeks] afterwards compared to 3 cases after tetracycline; estimated risk was 7.6 per 100,000 users). 8479374
Jick H, Derby LE, Dean AD, Henry DA. Flucloxacillin and cholestatic hepatitis. Med J Aust 1994; 160: 525. (Follow up of study by Derby et al.; risk of flucloxacillin cholestatic hepatitis in a new cohort was 6.5 per 100,000 users, with a rate similar to their previous estimate).
Eckstein RP, Dowsett JF, Lunzer MR. Flucloxacillin induced liver disease: histopathological findings at biopsy and autopsy. Pathology 1993; 25: 223-8. (Liver histology from 13 cases of flucloxacillin induced liver injury from Australia; ages 37-83 years given flucloxacillin for 5-23 days, onset 7-21 after stopping, mostly cholestatic; histology showed intrahepatic cholestasis, no granulomas, bile ductular injury, 3 of 4 with prolonged course had ductopenia). 8265236
Fairley CK, McNeil JJ, Desmond P, Smallwood R, Young H, Forbes A, Purcell P, et al. Risk factors for development of flucloxacillin associated jaundice. BMJ 1993; 306: 233-5. (Review of cases from the Australia adverse drug reaction system tracing 51 cases and 199 controls; injury was associated with older age, longer therapy, concomitant drugs, but not alcohol, smoking, gender or other drug allergies). 8443520
Mazuryk H, Kastenberg D, Rubin R, Muñoz SJ. Cholestatic hepatitis associated with the use of nafcillin. Am J Gastroenterol 1993; 88: 1960-2. (80 year old developed pruritus and rash after 2 weeks of intravenous nafcillin [8 g/day], with subsequent jaundice [bilirubin rising from 5.7 to 15 mg/dL, ALT 117 U/L, Alk P 1,102 U/L; after month of jaundice, prednisone was started with prompt improvement). 8237951
Siegmund JB, Tarshis AM. Prolonged jaundice after dicloxacillin therapy. Am J Gastroenterol 1993; 88: 1299-300. (36 year old woman developed fatigue and jaundice 3 weeks after starting dicloxacillin [bilirubin 18.2 mg/dL, ALT 100 U/L, Alk P 312 U/L], with slow recovery even with prednisone; 3 years later, enzymes were still mildly elevated [ALT 44 U/L, Alk P 188 U/L]). 8338117
Koek GH, Stricker BH, Blok AP, Schalm SW, Desmet VJ. Flucloxacillin-associated hepatic injury. Liver 1994; 14: 225-9. (Description of 11 cases of flucloxacillin hepatotoxicity reported to Dutch Adverse Events Center over 10 years, onset in 10-30 days, cholestatic in 7, mixed in 3; 2 patients died; the rest resolved in an average of 10 weeks). 7997079
Saliba B, Herbert PN. Oxacillin hepatotoxicity in HIV-infected patients. Ann Intern Med 1994; 120: 1048. (Retrospective review found that 81% [9/11] of HIV-positive, but only 4.5% [3/66] of HIV-negative patients receiving iv oxacillin for more than 10 days developed ALT or AST >3 fold elevated).
Desmond PV. Flucloxacillin hepatitis--an Australian epidemic. Aust N Z J Med 1995; 25: 195-6. (Review of Australian experience with flucloxacillin, their most common cause of drug induced liver disease; average age 58 years, onset 16 days after stopping, chronic cholestasis frequent; fatality rate 5%). 7487684
Devereaux BM, Crawford DH, Purcell P, Powell LW, Roeser HP. Flucloxacillin associated cholestatic hepatitis. An Australian and Swedish epidemic? Eur J Clin Pharmacol 1995; 49: 81-5. (Review of literature and history of use and pattern and frequency of hepatic injury from flucloxacillin in Australia, Sweden and UK). 8751026
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J 1996; 109: 315-9. (Flucloxacillin ranked 6th as a cause of liver adverse drug reaction in New Zealand in 1990s). 8816722
Presti ME, Janney CG, Neuschwander-Tetri BA. Nafcillin-associated hepatotoxicity. Report of a case and review of the literature. Dig Dis Sci 1996; 41: 180-4. (63 year old developed jaundice after 5 days of intravenous nafcillin [bilirubin rising to 40 mg/dL, ALT ~210 U/L, Alk P ~375 U/L], lasting 2 months, previous history of dicloxacillin allergy-rash). 8565754
Saab S, Venkataramani A, Yao F. Possible granulomatous hepatitis after dicloxacillin therapy. J Clin Gastroenterol 1996; 22: 163-4. (74 year old developed rash 5 days after starting oral dicloxacillin [bilirubin 0.5 mg/dL, ALT 172 U/L, Alk P 183 U/L], biopsy showing a single granuloma and mild nonspecific changes, ultimately resolving within 4 months of stopping). 8742666
Goland S, Malnick SD, Gratz R, Feldberg E, Geltner D, Sthoeger ZM. Severe cholestatic hepatitis following cloxacillin treatment. Postgrad Med J 1998; 74: 59-60. (77 year old woman developed fever, rash and jaundice 2 weeks after stopping a 2 week course of cloxacillin and ofloxacin with bilirubin 12.9 mg/dL, ALT 144 U/L, Alk P 394 U/L; after a month of jaundice, prednisone introduced with prompt improvement). 9538497
Al-Homaidhi H, Abdel-Haq NM, El-Baba M, Asmar BI. Severe hepatitis associated with oxacillin therapy. South Med J 2002; 95: 650-2. (6 year old girl developed fever, abdominal pain and marked ALT elevation [peak 2,257 U/L] with normal Alk P and bilirubin [0.3 mg/dL] after 14 days of intravenous oxacillin, resolving within 3 weeks of stopping). 12081223
Trevenzoli M, Cattelan AM, Mencarelli R, Meneghetti F. Severe hepatitis associated with oxacillin therapy. South Med J 2003; 96: 324-5. (Letter in response to Al-Homaidhi [2002] describing 33 year old who developed liver injury [bilirubin 1.8 mg/dL, ALT 2440 U/L, Alk P 103 U/L] weeks after receiving a 4 day course of amoxicillin/clavulanate [not oxacillin as suggested by the title]).
Ibáñez L, Pérez E, Vidal X, Laporte JR; Grup d'Estudi Multicènteric d'Hepatotoxicitat Aguda de Barcelona (GEMHAB). Prospective surveillance of acute serious liver disease unrelated to infectious, obstructive, or metabolic diseases: epidemiological and clinical features, and exposure to drugs. J Hepatol 2002; 37: 592-600. (Survey of 107 cases of acute serious liver disease, not due to viruses, found no instances of drug induced liver injury due to penicillinase-resistant penicillins). 12399224
Maraqa NF, Gomez MM, Rathore MH, Alvarez AM. Higher occurrence of hepatotoxicity and rash in patients treated with oxacillin, compared with those treated with nafcillin and other commonly used antimicrobials. Clin Infect Dis 2002; 34: 50-4. (Retrospective analysis of laboratory tests from 222 children receiving outpatient parenteral oxacillin, nafcillin, clindamycin or other antibiotics found 12 cases of anicteric and self-limited hepatotoxicity, 9 [22%] from oxacillin, all hepatocellular with normal bilirubin, onset in 6-43 days, resolution in 1-3 weeks; none to nafcillin; 1 clindamycin, 1 ceftriaxone and 1 ampicillin/sulbactam/gentamicin). 11731945
Sgro C, Clinard F, Ouazir K, Chanay H, Allard C, Guilleminet C, Lenoir C, et al. Incidence of drug-induced hepatic injuries: a French population-based study. Hepatology 2002; 36: 451-5. (A population based study identified 34 cases of acute drug induced liver injury over a 3 year period, including 10 [25%] due to antibiotics; one was due to cloxacillin with a 5 day latency, mixed serum enzyme pattern and recovery within 2 weeks of stopping). 12143055
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Analysis of all fatal adverse drug event reports of liver injury in Sweden between 1966 and 2002, found 103 cases; most common causes were halothane [n=16], acetaminophen [14], flucloxacillin [9], and TMP-SMZ [6]). 16165719
Dobson JL, Angus PW, Jones R, Crowley P, Gow PJ. Flucloxacillin-induced aplastic anaemia and liver failure. Transpl Int 2005; 18: 487-9. (40 year old woman developed aplastic anemia and acute liver failure starting 4 weeks after starting 2 week course of flucloxacillin, reversed by liver transplantation). 15773973
Hussaini SH, O'Brien CS, Despott EJ, Dalton HR. Antibiotic therapy: a major cause of drug-induced jaundice in southwest England. Eur J Gastroenterol Hepatol 2007; 19: 15-20. (Review of causes of non-obstructive jaundice in 347 patients presenting between 1998 and 2004 at a single UK center, 28 were thought to be drug induced liver injury [8.1%] and antibiotics were the most common cause, 32% amoxicillin/clavulanate, 25% flucloxacillin, 18% other). 17206072
Lee CY, Chen PY, Huang FL, Chi CS. Reversible oxacillin-associated hepatitis in a 9-month old boy. J Paediatr Child Health 2008; 44: 146-8. (9 month old boy given intravenous oxacillin for septic arthritis for 8 days when he developed lethargy and marked elevations in ALT [1568 U/L], with normal Alk P and bilirubin and resolving within 10 days of switching to teicoplanin). 18307421
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, antimicrobials accounted for 45% of cases with 23 single agent cases due to amoxicillin/clavulanate, 13 nitrofurantoin, 10 fluoroquinolones, 9 macrolides, 9 sulfonamides, 5 cephalosporins, 3 oxacillin, 2 doxycycline, 2 amoxicillin, and one each for gentamicin, imipenem, and clindamycin, but none from dicloxacillin or nafcillin). 18955056
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; leading causes were antituberculosis agents [58%], anticonvulsants [11%] and NSAIDs [2%]; specific antibiotic agents included sulfamethoxazole/ trimethoprim [2%] and amoxicillin-clavulanate [1%]). 20648003
Ferrajolo C, Capuano A, Verhamme KMC, Schuemie M, Rossi F, Stricker BH, Sturkenboom CJM. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Among 624,673 adverse drug reports in children in a worldwide pharmacovigilance database, 6595 [1%] were for hepatic injury and antibacterials accounted for 11%, those with the highest adjusted odds ratios being aztreonam, erythromycin, ceftriaxone and minocycline; no mention of penicillins). 21039766
Li L, Jick H, Jick SS. Updated study on risk of cholestatic liver disease and flucloxacillin. Br J Clin Pharmacol 2009; 68: 269-70. (Analysis of UK General Practice Research Database showed risk of cholestatic liver disease within 45 days of first time use of flucloxacillin was stable between 1985-2007 [6.1-8.5/100,000 users compared to 0.3/100,000 users of penicillin V]). 19694748
Daly AK, Donaldson PT, Bhatnagar P, Shen Y, Pe'er I, Floratos A, Daly MJ, et al. HLA-B*5701 genotype is a major determinant of drug-induced liver injury due to flucloxacillin. Nature Genetics 2009; 41: 816-9. (Genome-wide association study [GWAS] in 51 cases of flucloxacillin liver injury and 285 controls found an association with a single nucleotide polymorphism linked to HLA-B*5701 [84% in cases vs 5% in controls], the same genotype associated with abacavir hypersensitivity; ~0.2% of persons with this HLA type receiving flucloxacillin develop cholestatic hepatitis, making it likely that other genes or factors are important as well). 19483685
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 66 due to antimicrobial agents, but none were attributed to a penicillinase-resistant penicillin). 20949552
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: pathomechanisms and clinical data. Infection 2010; 38: 3-11. (Review of hepatotoxicity of antibiotics, mentions that cholestatic hepatitis has been reported with many beta-lactams and beta-lactamases inhibitors). 20107858
Daly AK. Genome-wide association studies in pharmacogenomics. Nat Rev Genet 2010; 11: 241-6. (Review of recent advances in GWAS studies of pharmacokinetics and adverse drug reactions and association of flucloxacillin injury with HLA-B*5701). 20300088
Robles M, Toscano E, Cotta J, Lucena MI, Andrade RJ. Antibiotic-induced liver toxicity: mechanisms, clinical features and causality assessment. Curr Drug Saf 2010; 5: 212-22. (Review of antibiotic hepatotoxicity mentions that flucloxacillin is the second most common cause of liver injury in many countries). 20210729
Alam MB, Kadoura A, Sathaiah M. A fatal case of nafcillin-induced hepatotoxicity: a case report and the literature review. Case Rep Med 2012; 2012: 953714. (53 year old woman developed jaundice 15 days after starting intravenous nafcillin for osteomyelitis [bilirubin 9.6 mg/dL, ALT 24 U/L, Alk P 388 U/L], with worsening despite stopping nafcillin [bilirubin 28.7 mg/dL, ALT 24 U/L, Alk P >1884 U/L], and death from multiorgan failure 2 months later). 22844299
Urban TJ, Goldstein DB, Watkins PB. Genetic basis of susceptibility to drug-induced liver injury: what have we learned and where do we go from here? Pharmacogenomics 2012; 13: 735-8. (Editorial summarizing recent advances in studies on the genetics of drug induced liver injury including the association of flucloxacillin injury with HLA-B*57:01). 22594502
Monshi MM, Faulkner L, Gibson A, Jenkins RE, Farrell J, Earnshaw CJ, Alfirevic A, et al. Human leukocyte antigen (HLA)-B*57:01-restricted activation of drug-specific T cells provides the immunological basis for flucloxacillin-induced liver injury. Hepatology 2013; 57: 727-39. (T cells from persons with HLA-B*57:01 were activated when exposed to dendritic cells presenting flucloxacillin bound to albumin, and were similarly activated by oxacillin, cloxacillin and dicloxacillin). 22987284
Sistanizad M, Peterson GM. Drug-induced liver injury in the Australian setting. J Clin Pharm Ther 2013; 38: 115-20. (Among 17 persons with suspected drug induced liver injury seen over at 12 month period at a referral hospital in Tasmania, 11 were attributed to antibiotics including 4 to flucloxacillin, 2 amoxicillin with clavulanate, 2 amoxicillin, and 1 each to rifampin, moxifloxacin and ciprofloxacin). 23350857
Wuillemin N, Adam J, Fontana S, Krähenbühl S, Pichler WJ, Yerly D. HLA haplotype determines hapten or p-i T cell reactivity to flucloxacillin. J Immunol 2013; 190: 4956-64. (Analysis of T cell responses in persons with and without HLA-B*57:01 suggested a pharmacological interaction of flucloxacillin with immune receptors on T cells, underlies the HLA association with flucloxacillin hepatoxicity). 23596311
Vera JH, Naous N, Mackie N, Winston A, Cooke G. The safety of flucloxacillin in HIV-infected patients with positive HLA-B*5701 genotype. AIDS 2013; 27: 484-5. (Among 10 persons with HIV infection with HLA-B*57:01 who received a course of flucloxacillin, none developed evidence of liver injury, suggesting that it is safe to use in this population of HLA-tested individuals). 23032409
Phillips EJ, Mallal SA. HLA-B*5701 and flucloxacillin associated drug-induced liver disease. AIDS 2013; 27: 491-2. (Letter in response to Vera [2013] arguing that the positive predictive value of HLA-B*5701 is only 0.12%, making screening an inefficient means of avoiding flucloxacillin hepatotoxicity and accounting for their negative findings because of the few patients tested). 23291545
Kaniwa N, Saito Y. Pharmacogenomics of severe cutaneous adverse reactions and drug-induced liver injury. J Hum Genet 2013; 58: 317-26. (Review of genetic studies of severe cutaneous and hepatic adverse events; HLA DRB*5701 has been associated with flucloxacillin hepatotoxicity, mainly in Europeans [Daly 2009]). 23635947
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 36 [37%] due to antibiotics and specifically dicloxacillin in 1 of 22,320 patients treated and cloxacillin in 1 of 3659 patients treated). 23419359
Wuillemin N, Terracciano L, Beltraminelli H, Schlapbach C, Fontana S, Krähenbühl S, Pichler WJ, et al. T cells infiltrate the liver and kill hepatocytes in HLA-B(*)57:01-associated floxacillin-induced liver injury. Am J Pathol 2014; 184: 1677-82. (Analysis of T cells from HLA-B*57:01 positive, healthy, non-flucloxacillin exposed controls demonstrated cytotoxicity of their CD8 cells by exposure to increasing concentrations of flucloxacillin with HLA-linked target cells). 24731753
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, Chirino RA, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, of which 37 [19%] were attributed to antimicrobials, but none to penicillinase resistant penicillins such as oxacillin or dicloxacillin). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 cases [36%] were attributed to antibiotics 3 of which were due to oxacillin, all being self-limited episodes of aminotransferase elevations without jaundice; no instances of dicloxacillin or nafcillin associated liver injury). 25754159
Yaseen FS, Saide K, Kim SH, Monshi M, Tailor A, Wood S, Meng X, et al. Promiscuous T-cell responses to drugs and drug-haptens. J Allergy Clin Immunol 2015; 136: 474-6.e8. (T cell clones from patients with flucloxacillin induced liver injury are HLA-restricted and are activated by via a hapten mechanism, unlike T cells clones from HLA-allele matched healthy controls which are activated by the native drug). 25910715
Ramírez A, Abril JC, Cano J. DRESS syndrome due to antibiotic therapy of osteoarticular infections in children: two case reports. Rev Esp Cir Ortop Traumatol 2015; 59: 360-4. (2 children, aged 7 with septic arthritis and age 8 with osteomyelitis, developed fever and rash 7 and 16 days after starting cefotaxime and cloxacillin [ALT 55 and 281 U/L, bilirubin and Alk P not provided], resolving within 3 weeks of stopping antibiotics). 25052739
Faulkner L, Gibson A, Sullivan A, Tailor A, Usui T, Alfirevic A, Pirmohamed M, et al. Detection of primary T cell responses to drugs and chemicals in HLA-typed volunteers: implications for the prediction of drug immunogenicity. Toxicol Sci 2016; 154: 416-29. (Demonstration of T cell priming to drugs linked with specific class I HLA-alleles). 27637899
Nicoletti P, Aithal GP, Bjornsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al.; International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. Association of liver injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology 2017; 152: 1078-89. (A genome wide association study done on 862 patients with drug induced liver injury demonstrated a strong link with HLA-A*33:01 in patients with cholestatic liver injury, particularly in cases attributed to terbinafine, fenofibrate and ticlopidine). 28043905
Usui T, Naisbitt DJ. Human leukocyte antigen and idiosyncratic adverse drug reactions. Drug Metab Pharmacokinet 2017; 32: 21-30. (Review of the association of specific forms of idiosyncratic drug reactions and HLA alleles focusing on class I alleles linked with abacavir [B*57:01], allopurinol [B*58:01], carbamazepine [B*15:02], amoxicillin/clavulanate [A*02:01], and flucloxacillin [B*57:01]). 28017537
Rao Q, Schuster I, Seoud T, Zarrabi K, Goolsarran N. A patient with nafcillin-associated drug-induced liver failure. Case Rep Gastroenterol 2017; 11: 564-8. (68 year old man with osteomyelitis developed jaundice 4 weeks after starting intravenous nafcillin, 2 g every 4 hours [bilirubin 9.4 rising to 14.1 mg/dL, ALT 127 U/L, Alk P 311 U/L, INR 1.6, eosinophils 21%], worsening for 7 days after stopping, but then resolving and 6 months later had normal liver tests). 29033779
Wing K, Bhaskaran K, Pealing L, Root A, Smeeth L, van Staa TP, Klungel OH, et al. Quantification of the risk of liver injury associated with flucloxacillin: a UK population-based cohort study. J Antimicrob Chemother 2017; 72: 2636-46. (Among 861,962 individuals given a first prescription of flucloxacillin and followed for the next 45 days in the UK Clinical Practice Research Datalink, 122 developed symptoms of jaundice [14.2 per 100,000 or ~1 in 7000] and 73 had laboratory confirmed liver injury [8.5 per 100,000 or ~1 in 12,000], and rates were higher with consecutive prescriptions and in older age groups). 28859440
Visentin M, Lenggenhager D, Gai Z, Kullak-Ublick GA. Drug-induced bile duct injury. Biochim Biophys Acta Mol Basis Dis 2018; 1864(4 Pt B): 1498-506. (Review of drug induced bile duct injury focusing on agents flucloxacillin and amoxicillin/clavulanate that injure small ducts and fluorouracil [given by hepatic artery], ketamine, scolicidal agents [for Hydatid disease given into the cysts] that injure larger ducts causing a sclerosing cholangitis like picture). 28882625
Lavergne A, Vigneau C, Polard E, Triquet L, Rioux-Leclercq N, Tattevin P, Golbin L. Acute kidney injury during treatment with high-dose cloxacillin: a report of 23 cases and literature review. Int J Antimicrob Agents 2018; 52: 344-9. (Among 23 patients with suspected cloxacillin induced renal dysfunction [19 had also received gentamicin], the median age was 75, duration of therapy 4 days, dose 12 gm daily and peak creatinine 3.8 mg/dL, all resolving after stopping therapy; 8 patients had abnormal liver tests but no details provided). 29665445
Takeuchi Y, Shinozaki T, Kumamaru H, Hiramatsu T, Matsuyama Y. Analyzing intent-to-treat and per-protocol effects on safety outcomes using a medical information database: an application to the risk assessment of antibiotic-induced liver injury. Expert Opin Drug Saf 2018; 17: 1071-9. (Cohort matching of cases with vs without antibiotic therapy in a large electronic medical record database from the University of Tokyo Hospital from 2011 to 2015 with adjustments, found rates of liver test abnormalities within 30 days of starting penicillins [25.2 per 1000] were higher than that of fluoroquinolones [11.4] and macrolide antibiotics [8.1] as well as controls [6.5 to 7.1]). 30252549
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Bjornsson ES, Chalasani N, Fontana RJ, et al.; Drug-Induced Liver Injury Network (DILIN) investigators; International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology 2019; 156: 1707-1716.e2. (Genome-wide association studies on 2048 patients with drug induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions). 30664875
Nicoletti P, Aithal GP, Chamberlain TC, Coulthard S, Alshabeeb M, Grove JI, Andrade RJ, et al.; International Drug-Induced Liver Injury Consortium (iDILIC). Drug-induced liver injury due to flucloxacillin: relevance of multiple human leukocyte antigen alleles. Clin Pharmacol Ther 2019; 106: 245-53. (Among 197 patients with flucloxacillin induced liver injury, the allele frequency for HLA-B*57:01 was 0.42 compared to 0.04 among population controls and HLA-B*57:03, although rare was also significantly associated with allele frequency of 0.005 compared to 0.0003 in controls, both B*57 alleles sharing a valine at position 97 of the HLA protein). 30661239
Hashim A, Barnabas A, Miquel R, Agarwal K. Successful liver transplantation for drug-induced vanishing bile duct syndrome. BMJ Case Rep 2020; 13: e233052. (63 year old man developed jaundice shortly after completing a 10 day course of flucloxacillin which worsened over the next 3 months [bilirubin 29.3 mg/dL, ALT 60 U/L, Alk P 229 U/L, INR 1.0], liver biopsy showing bland cholestasis and rare bile duct loss, eventually undergoing successful liver transplant 6 months after presentation; genetic testing revealed homozygosity for a BSEP [ABC B11] mutation which may have contributed to the poor outcome).
Teixeira M, Macedo S, Batista T, Martins S, Correia A, Matos LC. Flucloxacillin-induced hepatotoxicity - association with HLA-B*5701. Rev Assoc Med Bras 2020; 66(1): 12-7. (74 year old man developed abdominal pain 2 weeks after a second 8 day course of flucloxacillin [bilirubin 3.3 rising to 24.1 mg/dL, ALT 646 U/L, Alk P 302 U/L, GGT 662 U/L] with persistence of jaundice for 3 months and abnormalities of Alk P and GGT for more than a year; HLA testing revealed B*57:01, an allele often associated with flucloxacillin liver injury). 32130375
Nicoletti P, Aithal GP, Chamberlain TC, Coulthard S, Alshabeeb M, Grove JI, Andrade RJ, et al; International Drug-Induced Liver Injury Consortium (iDILIC). Drug-induced liver injury due to flucloxacillin: relevance of multiple human leukocyte antigen alleles. Clin Pharmacol Ther. 2019;106:245-253. (Among 197 patients with flucloxacillin-induced liver injury, genome wide association studies demonstrated a strong association with HLA-B*57:01 compared to controls [AF .42 vs .04], but the allele was not found increased among 6 patients with oxacillin-, dicloxacillin-. or cloxacillin-induced liver injury or in 15 with amoxicillin-induced liver injury). 30661239
Timbrook TT, McKay L, Sutton JD, Spivak ES. Disproportionality analysis of safety with nafcillin and oxacillin with the FDA Adverse Event Reporting System (FAERS). Antimicrob Agents Chemother. 2020;64:e01818-19. (Analysis of the FDA’s Adverse Event Reporting System [FAERS] between 2003 and 2018 found a similar proportion of hepatotoxicity cases attributed to oxacillin [20 of 289 total adverse event reports] compared to nafcillin [18 of 331] while reports of acute renal failure were less frequent with oxacillin vs nafcillin [13 vs 52]). 31844017
Hashim A, Barnabas A, Miquel R, Agarwal K. Successful liver transplantation for drug-induced vanishing bile duct syndrome. BMJ Case Rep. 2020;13:e233052. (63-year-old woman developed jaundice 4 days after finishing a 10-day course of flucloxacillin for a skin infection [bilirubin 29.3 mg/dL, ALT 60 U/L, Alk P 287 U/L] with progressive cholestasis leading to liver transplantation 6 months after initial onset). 31948982
Khatib S, Sabobeh T, Bock MD, Masoud A, Alallaf J. Nafcillin-induced hepatic injury: a case report and literature review. Cureus. 2021;13:e12817 (66 year old man with toe infection developed jaundice 9 days after finishing an 18-day course of iv nafcillin [bilirubin 6.2 mg/dL, ALT 415 U/L, Alk P 506 U/L] which worsened for a few days but then gradually resolved completely without corticosteroids or other specific therapy). 33628683
Angheleanu R, Swart JN. Flucloxacillin-induced liver injury in elderly patient. BMJ Case Rep. 2021;14:e241071. (A 91 year old woman developed dark urine, jaundice, and confusion 3 to 4 weeks after a 7- and then a 5-day course of flucloxacillin for cellulitis [bilirubin 14 mg/dL, ALT 116 U/L, Alk P 1083 U/L, INR 1.5] but ultimately improved with supportive therapy only and her condition “settled slowly” for the next 4 weeks). 33958360
Faragalla K, Lau H, Wang HL, Liu J. Cloxacillin-induced acute vanishing bile duct syndrome: a case study and literature review. Br J Clin Pharmacol. 2022;88:4633-4638. (66-year-old woman with cerebral vascular disease developed weakness and progressive jaundice a week after finishing a 6-week course of cloxacillin and sought medical care 2 weeks later [bilirubin of 44 mg/dL, ALT 877 U/L, Alk P 4279 U/L, eosinophils 1,200/μL], with persistence of jaundice and liver biopsy showing ductopenia was referred for liver transplant but died of complications before surgery). 35730139
Coombs S, Pittet LF, Tang K, Gwee A. Incidence and predisposing factors for flucloxacillin-related hepatotoxicity in children. J Antimicrob Chemother. 2023;78:2667-2671. (Among 393 children treated with iv flucloxacillin who had liver tests taken before and after therapy, 66 developed “hepatotoxicity” which was mostly isolated elevations in GGT, ALT, AST, or bilirubin with no serious outcomes or persistent injury). 37699070
Warring SR, Biggs JM, Morgan JA, Parbuoni KA. Comparison of adverse effect profiles of nafcillin and oxacillin in pediatric patients. J Pediatr Pharmacol Ther. 2024;29:645-649. (Among 17 children receiving iv nafcillin and 36 iv oxacillin for at least 48 hours at a single referral hospital, liver test abnormalities arose at equal rates [17%] and [18%] while creatinine elevations were more frequent with oxacillin [21% vs 30%]). 39659857
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1,739 hospitalizations for acute liver injury suspected to be due to outpatient prescribed medications none of which were attributed to a penicillinase-resistant penicillin). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database only 1 was attributed to oxacillin and none to other penicillinase-resistant penicillins: personal communication). 38992407
Huang YT, Huang YM, Lee NC, Lee PI, Ho YF. Medication hazards and outcome patterns of pediatric drug-associated liver injury in Taiwan: an analysis of 1998-2017 spontaneous adverse drug reaction reports. Drugs Real World Outcomes. 2025;12:105-114. (Among 16,673 spontaneous reports of adverse drug reactions in children made to a Taiwanese national registry between 1998 and 2017, 484 were liver related and attributed to 193 different drugs the most frequent implicated being oxacillin [25 reports] followed by methotrexate [20], phenobarbital [13], phenytoin [10] and valproate [10]). 39775441
Nibell O, Björk J, Nilsson A, Jacobsson G, Inghammar M. The risk of drug-induced liver injury associated with flucloxacillin: a nationwide, entropy-balanced cohort study. Clin Microbiol Infect. 2025;31:600-606. (Analysis of Swedish national registries of drug prescriptions and cases of drug induced liver disease occurring within 45 days of the prescription between 2006 and 2018 yielded rough estimates for incidence of liver injury as 1 in 525 cases per person exposed to flucloxacillin [219 cases in 1,129,091 individuals] vs 1 in 5,250 exposed to clindamycin [9 cases in 471,666]). 39716553
Perez AD, Brenner AL, Pieta E, Harrison R, Sultan S, Ponder MG, Daniels L. Incidence of acute kidney injury with the use of nafcillin versus oxacillin. Pharmacotherapy. 2026;46:e70145. (Among 171 hospitalized patients treated with nafcillin between 2020 and 2024 vs 467 with oxacillin between 2015 and 2020, acute renal injury occurred more frequently with nafcillin vs oxacillin [33% vs 20%], in-hospital mortality was greater [13% vs 6%], and liver test elevations above 3 times ULN more common [17% vs 9%]: details of liver tests not provided). 41998805
Burdet C, Saïdani N, Dupieux C, Lemaignen A, Canouï E, Surgers L, Vareil MO, et al.; CloCeBa Study Group. Cloxacillin versus cefazolin for methicillin-susceptible Staphylococcus aureus bacteraemia (CloCeBa): a prospective, open-label, multicentre, non-inferiority, randomised clinical trial. Lancet. 2025;406(10517):2349-2359. (In a prospective, randomized controlled trial in hospitalized adults with methicillin-susceptible Staphylococcus aureus bacteremia treated iv with cefazolin [n=146] vs cloxacillin [n=146], clinical success without relapse was achieved at similar rates [75% vs 74%], while serious adverse events were less with cefazolin [15% vs 27%], the difference being in rates of acute renal injury [1% vs 12%], and not in liver enzyme elevations [1% vs 1%] or C. difficile infections [2% vs 2%]). 41115439
Staphylococcus aureus Network Adaptive Platform (SNAP) Trial Group; Lee TC, Barina LA, Walls G, Goodman AL, Yahav D, Cheng MP, Bonten M, et al. Cefazolin for methicillin-susceptible Staphylococcus aureus bacteremia. N Engl J Med. 2026;394:2329-2339. PMID: 42308484 (Among adults with methicillin-susceptible Staphylococcus aureus bacteremia treated with cefazolin [n=645] or a penicillase-resistant penicillin [flucloxacillin or cloxacillin: n=642], death within 90 days occurred in 15% vs 17% and serious adverse events in 1.8% vs 4.9%, the major difference being in rates of acute kidney injury [0.3% vs 1.8%] and not hepatotoxicity [0.2% vs 0.2%]).

## OTHER REFERENCE LINKS

1. Recent References on Penicillinase-Resistant Penicillins: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(dicloxacillin/AE+OR+nafcillin/AE+OR+oxacillin/AE+OR+cloxacillin/AE+OR+flucloxacillin/AE+OR+methicillin/AE)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222008/03/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Penicillinase-Resistant Penicillins: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=dicloxacillin+OR+nafcillin+OR+oxacillin+OR+cloxacillin+OR+flucloxacillin+OR+methicillin)